# Antiinfective Agents

## OVERVIEW

The following drug records are discussed individually:

- Antibacterial Agents: Classes
  - Aminoglycosides; Carbapenems; Cephalosporins; Fluoroquinolones; Glycopeptides; Macrolide Antibiotics; Penicillins (1^st^ Gen Penicillins) (2^nd^ Gen Penicillins) (3^rd^ Gen Penicillins) (4^th^ Gen Penicillins); Sulfonamides; Tetracyclines
- Antibacterial Agents: Miscellaneous Agents
  - Aztreonam, Benznidazole, Chloramphenicol, Clindamycin, Daptomycin, Fosfomycin, Lefamulin, Linezolid, Methenamine, Metronidazole, Nitrofurantoin, Quinupristin-Dalfopristin, Secnidazole, Tedizolid, Tinidazole, Vancomycin
- Antifungal Agents
- Anthelmintic Agents
- Antimalarial Agents
- Antitoxins
  - Bezlotoxumab, Obiltoxaximab, Raxibacumab
- Antituberculosis Agents
- Antiviral Agents
- Leishmaniasis Agents
  - Miltefosine
- Leprosy Agents
- Clofazimine, Dapsone, Rifampin
- Trypanosomiasis Agents
  - Benznidazole, Fexinidazole, Nifurtimox